# Gefitinib

## OVERVIEW

### Introduction

Gefitinib is a selective tyrosine kinase receptor inhibitor used in the therapy of non-small cell lung cancer. Gefitinib therapy is associated with transient elevations in serum aminotransferase levels and rare instances of clinically apparent acute liver injury.

### Background

Gefitinib (ge fi' ti nib) is a selective inhibitor of the tyrosine kinase receptor of epidermal growth factor (EGFR), which is often mutated and over expressed in cancer cells, particularly non-small cell lung cancer and some forms of breast cancer. The mutated EGF tyrosine kinase receptor is constitutively expressed which causes unregulated cell growth and proliferation. By inhibition of this growth factor receptor, gefitinib blocks the intracellular Ras signaling transduction cascade, which results in inhibition of the malignant cell growth. Highest rates of response to gefitinib are seen in patients with activating mutations of EGFR in the tumor tissue. Gefitinib received approval for use in the United States in 2009 for the treatment of advanced non-small cell lung cancer after failure of other therapies, but has been available in Japan since 2002. Gefitinib is available in tablets of 250 mg under the brand name Iressa. The recommended dose is 250 mg by mouth once daily, with dose modification based upon tolerance. Side effects are common and include diarrhea, nausea, vomiting, anorexia, mouth ulcers, conjunctivitis, rash, pruritus and fatigue. Uncommon serious side effects include interstitial lung disease and corneal erosions.

### Hepatotoxicity

In large early clinical trials, elevations in serum aminotransferase levels occurred in 9% to 13% of patients treated with standard doses of gefitinib, and 2% to 4% of patients had to stop therapy because of elevations above 5 times the upper limit of normal. Serum enzyme elevations typically arise after 4 to 12 weeks of treatment with a hepatocellular pattern. Immunoallergic and autoimmune features have not been described, but rash is common in patients receiving gefitinib. Most cases of liver injury due to gefitinib in the literature have been minimally or not symptomatic, and the injury resolved within 1 to 2 months of stopping the drug. Restarting therapy was usually but not always followed by rapid recurrence of serum enzyme elevations, and corticosteroid therapy did not appear to prevent this recurrence. In some instances, lower doses were tolerated with minimal or no ALT elevations. Periodic monitoring of liver tests during therapy is recommended. Despite the frequency of serum aminotransferase elevations during gefitinib therapy, cases of clinically apparent liver injury with jaundice are rare. Cases of severe and fatal hepatotoxicity have been reported to the sponsor and monitoring of liver tests during therapy is recommended.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury due to gefitinib is unknown. Gefitinib is metabolized in the liver largely via CYP 3A4, and liver injury may be due to accumulation of a toxic or immunogenic intermediate.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose interruption. If changes persist, are severe, or reoccur on restarting, gefitinib should be discontinued. There have been no published reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to gefitinib but the product label mentions severe hepatotoxicity with fatalities occurring in 0.04% of patients. Patients with liver abnormalities during gefitinib therapy generally tolerate other tyrosine kinase receptor inhibitors without recurrence of severe injury.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORT

### Case 1. Serum aminotransferase elevations during gefitinib therapy.

[Modified from: Takeda M, Okamoto I, Fukuoka M, Nakagawa K. Successful treatment with erlotinib after gefitinib-related severe hepatotoxicity. J Clin Oncol 2010; 28: e273-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20385983)]

A 66 year old woman with metastatic non-small cell adenocarcinoma of the lung developed serum aminotransferase elevations during therapy with gefitinib (250 mg daily). She was a nonsmoker and the lung cancer was shown to harbor a deletion in exon 19 of the epidermal growth factor receptor gene, which has been shown to confer sensitivity to inhibition by gefitinib. Serum aminotransferase levels were normal before and during the first 8 weeks of treatment, but became moderately elevated at week 13 (Table). Nevertheless, gefitinib was continued and ursodiol and glycyrrhizate [an herbal medication used in Japan as therapy of liver disease] were started. Serum enzymes gradually improved. However, 36 weeks after starting gefitinib, ALT levels rose markedly [ALT 1011 and AST 599 U/L] and gefitinib was stopped. She was taking no other medications. Abdominal ultrasound was unremarkable. Serum enzymes decreased with stopping gefitinib and 7 weeks later they were normal. Erlotinib (150 mg daily) was started and serum aminotransferase levels remained normal during long term therapy (15 weeks at the time of the report).

#### Key Points

Medication: | Gefitinib (250 mg daily)
Pattern: | Hepatocellular (R=unable to calculate)
Severity: | 1+ (serum enzyme elevations only)
Latency: | 12 weeks to initial elevations, 36 weeks to marked elevations
Recovery: | 7 weeks
Other medications: | Initially none; later ursodiol and glycyrrhizate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Other
0 | Pre | 20 | 20 | Gefitinib started
8 weeks | | 30 | 30
13 weeks | | 181 | 84
14 weeks | | 200 | 86
16 weeks | | 120 | 80
22 weeks | | 80 | 60
26 weeks | | 40 | 40
29 weeks | | 35 | 40
33 weeks | | 100 | 70
36 weeks | 0 | 750 | 410 | Gefitinib stopped
38 weeks | 2 weeks | 1011 | 599
40 weeks | 4 weeks | 410 | 100
42 weeks | 6 weeks | 70 | 70
44 weeks | 2 months | 40 | 40 | Erlotinib started
12 months | 3 months | 35 | 30
14 months | 5 months | 20 | 20
Normal Values | | <35 | <40

* Selected values estimated from Figure 1.

#### Comment

Elevations in serum aminotransferase levels occur in at least 10% of patients treated with gefitinib, but they are usually mild and self-limited and rise to above 5 times the upper limit (approximately 200 U/L) in only 2% to 4% of patients, and even then may not require drug discontinuation. In this patient, the serum aminotransferase levels rose to more than 20 times the upper limit of normal which led to immediate discontinuation of therapy. Glycyrrhizate is an extract of licorice which is used in Japan as a hepatoprotective agent and usually given intravenously one to three times weekly, but its dose and regimen were not provided in this report. The authors also do not mention whether the patient was symptomatic or jaundiced and results of serum alkaline phosphatase, bilirubin and prothrombin time were not given, nor was information provided about previous liver disease, alcohol use, or results of virologic and immunologic tests to rule out other causes of liver injury. Nevertheless, the timing of presentation and prompt improvement on stopping gefitinib are convincing as was the lack of recurrence with erlotinib treatment. Monitoring of serum enzymes during gefitinib and erlotinib therapy is warranted and the agents should be discontinued if symptoms or jaundice arise or aminotransferase levels remain above 5 times the upper limit of normal in the absence of other possible etiologies.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gefitinib – Iressa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gefitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gefitinib | 184475-35-2 | C22-H24-Cl-F-N4-O3 | Gefitinib Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 March 2018

Abbreviations: EGFR, epidemal growth factor receptor; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; gefitinib has been linked to reversible serum aminotransferase elevations, but not clearly to symptomatic, clinically apparent liver injury).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Fukuoka M, Yano S, Giaccone G, Tamura T, Nakagawa K, Douillard JY, Nishiwaki Y, et al. Multi-institutional randomized phase II trial of gefitinib for previously treated patients with advanced non-small-cell lung cancer. J Clin Oncol 2003; 21: 2237-46. (Among 210 patients with advanced lung cancer treated with two doses of gefitinib, serum ALT elevations occurred in 14%, were above 5 times ULN in 4.7%, and 4 patients [2%] withdrew from therapy for serum enzyme elevations). 12748244
Kris M, Natale RB, Herbst R, Lynch TJ Jr, Prager D, Belani CP, Schiller JH, et al. Efficacy of gefitinib, an inhibitor of the epidermal growth factor receptor tyrosine kinase, in symptomatic patients with non-small cell lung cancer. JAMA 2003; 290: 2149-58. (Among 216 patients with advanced lung cancer treated with two doses of gefitinib for an average of 2 months, elevations in ALT >5 times ULN occurred in 3 [1.5%], but none developed symptomatic hepatitis with jaundice). 14570950
Lynch TJ, Bell DW, Sordella R, Gurubhagavatula S, Okimoto RA, Brannigan BW, Harris PL, et al. Activating mutations in the epidermal growth factor receptor underlying responsiveness of non-small-cell lung cancer to gefitinib. N Engl J Med. 2004; 350: 2129-39. (A mutation in EGF tyrosine kinase receptor was identified in 8 of 9 tumors from patients with a clinical response to gefitinib, but in 0 of 7 nonresponders; in vitro, the mutated receptor was more sensitive than the wild type to inhibition by gefitinib). 15118073
Birnbaum A, Ready N. Gefitinib therapy for non-small cell lung cancer. Curr Treat Options Oncol 2005; 6: 75-81. (Review of efficacy and safety of gefitinib therapy for non-small cell lung cancer; hepatotoxicity is not discussed). 15610717
Kindler HL, Friberg G, Skoog L, Wade-Oliver K, Vokes EE. Phase I/II trial of gefitinib and oxaliplatin in patients with advanced colorectal cancer. Am J Clin Oncol 2005; 28: 340-4. (14 patients with advanced lung cancer were treated with gefitinib and oxaliplatin; mild serum ALT elevations occurred in 9 patients [64%]). 16062074
Ho C, Davis J, Anderson F, Bebb G, Murray N. Side effects related to cancer treatment: CASE 1. Hepatitis following treatment with gefitinib. J Clin Oncol 2005; 23: 8531-3. (57 year old woman with advanced lung cancer developed abnormal liver tests 8 weeks after starting gefitinib [AST ~800 U/L], which resolved in 2 months but recurred within a week of restarting [AST~520 U/L], resolving again and recurring even with concurrent prednisone). 16293881
Seki N, Uematsu K, Shibakuki R, Eguchi K. Promising new treatment schedule for gefitinib responders after severe hepatotoxicity with daily administration. J Clin Oncol 2006; 24: 3213-4; author reply 3214-5. (Letter in response to Ho [2005] describing 61 year old Japanese woman who had a clinical response to gefitinib therapy, but developed serum ALT elevations after 8 weeks of therapy, recurring on rechallenge, but later tolerated gefitinib with minimal ALT elevations when given every 5 days instead of daily). 16809744
Fujiwara Y, Kiura K, Toyooka S, Takigawa N, Tokumo M, Hotta K, Aoe M, et al. Relationship between epidermal growth factor receptor gene mutations and the severity of adverse events by gefitinib in patients with advanced non-small cell lung cancer. Lung Cancer 2006; 52: 99-103. (Among 26 patients with non-small cell lung cancer [NSCLC] treated with gefitinib, 11 had EGFR mutations in tumor tissue which correlated with tumor response [78% vs 21% in those without], but not with side effects [any ALT elevation in 36% vs 7%, ALT >5 times ULN in 0% vs 7%]). 16503086
Reck M, Buchholz E, Romer KS, Krutzfeldt K, Gatzemeier U, Manegold C. Gefitinib monotherapy in chemotherapy-naive patients with inoperable stage III/IV non-small-cell lung cancer. Clin Lung Cancer 2006; 7: 406-11. (Among 58 patients with advanced NSCLC treated with gefitinib, common toxicities were rash, diarrhea, nausea and fatigue; ALT changes not mentioned). 16800967
Carlini P, Papaldo P, Fabi A, Felici A, Ruggeri EM, Milella M, Ciccarese M, et al. Liver toxicity after treatment with gefitinib and anastrozole: drug-drug interactions through cytochrome p450? J Clin Oncol 2006; 24: e60-1. (Letter in response to Ho [2005] describing a 63 year old woman with lung cancer who developed rising ALT elevations after 16 weeks of gefitinib therapy [ALT 77 to 213 U/L], which decreased on stopping and rapidly recurred on restarting). 17158530
Jiang H. Overview of gefitinib in non-small cell lung cancer: an Asian perspective. Jpn J Clin Oncol 2009; 39: 137-50. (Systematic review of the literature on gefitinib therapy of NSCLC, focusing upon differences in response rates between Asian and Western patients that is probably due to different rates of activating mutations; rates of adverse events are similar in Asian and non-Asian patients). 19088154
Sanford M, Scott LJ. Gefitinib: a review of its use in the treatment of locally advanced/metastatic non-small cell lung cancer. Drugs 2009; 69: 2303-28. (Review of the pharmacology, efficacy and safety of gefitinib; overall rate of serum enzyme elevations of >5 times ULN was 9% with gefitinib vs 1% in comparative regimens; severe side effects are more common in elderly). 19852530
Ohashi Y, Suzuki K, Sakurai M, Ishikawa H, Onishi T, Nakagaki S, Kato T, et al. [Safety analysis of eight patients treated with erlotinib after severe gefitinib-induced liver injury]. Gan To Kagaku Ryoho 2010; 37: 1307-11. Japanese. (Abstract only: among 8 patients who developed marked serum ALT elevations on gefitinib therapy, only one had recurrence [with skin rash] when switched to erlotinib). 20647715
Kim ST, Lee J, Kim JH, Won YW, Sun JM, Yun J, Park YH, et al. Comparison of gefitinib versus erlotinib in patients with non-small cell lung cancer who failed previous chemotherapy. Cancer 2010; 116: 3025-33. (Retrospective analysis of 467 patients with NSCLC treated with either gefitinib or erlotinib found similar rates of clinical response; no discussion of adverse events). 20564408
Campbell L, Blackhall F, Thatcher N. Gefitinib for the treatment of non-small-cell lung cancer. Expert Opin Pharmacother 2010; 11: 1343-57. (Review of structure, mechanism of action, pharmacology, efficacy and safety of gefitinib; "Asymptomatic elevations in liver transaminases and bilirubin also occurred commonly but usually recovered upon discontinuation of therapy. Rarely did hepatitis occur"). 20426712
Takeda M, Okamoto I, Fukuoka M, Nakagawa K. Successful treatment with erlotinib after gefitinib-related severe hepatotoxicity. J Clin Oncol 2010; 28: e273-4. (66 year old woman with lung cancer developed ALT elevations after 36 weeks of treatment with gefitinib [ALT peak ~1011 U/L], resolving within 8 weeks of stopping and not recurring on starting erlotinib: Case 1). 20385983
Ku GY, Chopra A, de Lima Lopes G Jr. Successful treatment of two lung cancer patients with erlotinib following gefitinib-induced hepatotoxicity. Lung Cancer 2010; 70: 223-5. (Two men, ages 52 and 88 years, withNSCLC developed serum ALT elevations 4 and 6 weeks after starting gefitinib [bilirubin normal, peak ALT 354 and 297 U/L], resolving rapidly on stopping and not recurring when switched to erlotinib). 20817304
Yin YM, Geng YT, Shao YF, Hu XL, Li W, Shu YQ, Wang ZX. First-line single agent treatment with gefitinib in patients with advanced non-small-cell lung cancer. J Exp Clin Cancer Res 2010; 29: 126. (Among 45 Chinese patients with NSCLC treated with gefitinib, liver test abnormalities occurred in 3 [7%], but were mild and self-limited). 20843324
Nakatomi K, Nakamura Y, Tetsuya I, Kohno S. Treatment with gefitinib after erlotinib-induced liver injury: a case report. J Med Case Reports 2011; 5: 593. (31 year old woman with metastatic lung cancer developed enyzme elevations 4 weeks after starting erlotinib [peak ALT 3130 U/L] that fell to normal within 3 weeks of stopping and did not rise again when she was started on gefitinib). 22188652
Kijima T, Shimizu T, Nonen S, Furukawa M, Otani Y, Minami T, Takahashi R, et al. Safe and successful treatment with erlotinib after gefitinib-induced hepatotoxicity: difference in metabolism as a possible mechanism. J Clin Oncol 2011; 29: e588-90. (Two women, ages 67 and 83 years, with lung cancer developed elevated aminotransferase levels 4 and 8 weeks after starting gefitinib [peak ALT 731 and ~450 U/L, bilirubin and Alk P not given], which resolved upon stopping, recurred on restarting, but did not recur when erlotinib was used). 21502555
Lai YC, Lin PC, Lai JI, Hsu SY, Kuo LC, Chang SC, Wang WS. Successful treatment of erlotinib-induced acute hepatitis and acute interstitial pneumonitis with high-dose corticosteroid: a case report and literature review. Int J Clin Pharmacol Ther 2011 Jul; 49: 461-6. (74 year old man developed interstitial pneumonitis and mild serum enzyme elevations 1 month after starting erlotinib [ALT 116 U/L], both of which improved within days on high dose corticosteroids). 21726497
Chen J, Gu R, Wang Q, Dassarath M, Yin Z, Yang K, Wu G. Gefitinib-induced hepatotoxicity in patients treated for non-small cell lung cancer. Onkologie 2012; 35: 509-13. (Among 92 patients with NSCLC treated with gefitinib, 6 [7%] had ALT elevations [range 47-91 U/L] arising 1 week to 6 months after starting, but only one required dose adjustment and all resolved). 23007149
Maemondo M, Minegishi Y, Inoue A, Kobayashi K, Harada M, Okinaga S, Morikawa N, et al. First-line gefitinib in patients aged 75 or older with advanced non-small cell lung cancer harboring epidermal growth factor receptor mutations: NEJ 003 study. J Thorac Oncol 2012; 7: 1417-22. (Among 31 elderly patients with NSCLC, 6 [19%] developed ALT or AST levels above 5 times ULN). 22895139
Kunimasa K, Yoshioka H, Iwasaku M, Nishiyama A, Korogi Y, Masuda G, Takaiwa T, et al. Successful treatment of non-small cell lung cancer with gefitinib after severe erlotinib-related hepatotoxicity. Intern Med 2012; 51: 431-4. (64 year old woman developed liver test elevations 5 weeks after starting erlotinib for NSCLC [bilirubin normal, ALT 129 rising to 617 U/L], recurring when erlotinib was restarted [ALT 1008 U/L by day 3], but not when switched to gefitinib). 22333382
Takimoto T, Kijima T, Otani Y, Nonen S, Namba Y, Mori M, Yokota S, et al. Polymorphisms of CYP2D6 gene and gefitinib-induced hepatotoxicity. Clin Lung Cancer 2013; 14 (5): 502-7. (Distribution of polymorphisms of CYP2D6 gene were similar in 55 patients who developed ALT elevations during gefitinib therapy as found in the general Japanese population; 17 patients were swithced to erlotinib and did not have recurrence). 23664723
Kitade H, Yamada T, Igarashi S, Hokkoku K, Mori M, Shintaku K, Sagawa M, et al. [Efficacy of low-dose erlotinib against gefitinib-induced hepatotoxicity in a patient with lung adenocarcinoma harboring EGFR mutations]. Gan To Kagaku Ryoho 2013; 40: 79-81. Japanese. (Abstract only: 80 year old woman developed ALT elevations [3-5 times ULN] during gefitnib therapy, which resolved on stopping and did not recur with erlotinib therapy given for 3 years). 23306923
Yoshida T, Yamada K, Azuma K, Kawahara A, Abe H, Hattori S, Yamashita F, et al. Comparison of adverse events and efficacy between gefitinib and erlotinib in patients with non-small-cell lung cancer: a retrospective analysis. Med Oncol 2013; 30: 349. (Comparison of side effects in 107 patients with NSCLC treated with gefitinib and 35 treated with erlotinib found "liver dysfunction" more frequent with gefitinib than erlotinib [13% vs 6%], whereas overall adverse events leading to drug discontinuation were less common [13% vs 26%]). 23263831
Chen X, Pan Y, Zhang S, Chen D, Yang S, Li X, Ma S. Rechallenge with gefitinibfollowing severe drug-induced hepatotoxicity in a patient with advanced non-small cell lung cancer: A case report and literature review. Oncol Lett 2014; 7: 878-80. (61 year old woman with NSCLC developed marked ALT elevations 14 months after starting gefitinib [ALT 1,130 U/L], which fell to near normal 10 weeks later and did not increase when gefitinib was restarted one year later). 24527096
Yonesaka K, Suzumura T, Tsukuda H, Hasegawa Y, Ozaki T, Sugiura T, Fukuoka M. Erlotinib is a well-tolerated alternate treatment for non-small cell lung cancer in cases of gefitinib-induced hepatotoxicity. Anticancer Res 2014; 34: 5211-5. (Among 25 patients with advanced NSCLC treated with gefitinib, 7 developed ALT elevations above 5 times ULN [specific values not given], all of whom then tolerated erlotinib with no or only minor enzyme elevations). 25202117
Durand M, Logerot S, Fonrose X, Schir E. [Treatment with erlotinib after gefitinib induced hepatotoxicity: literature review and case report]. Therapie 2014; 69: 163-8. French. (Patient with NSCLC developed marked ALT elevations on gefinitib therapy with positive rechallenge, who nevertheless subsequently tolerated erlotinib without recurrence: Abstract only). 24926635
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], 3 of which were attributed to kinase inhibitors [imatinib, lapatinib], but none to erlotinib or gefitinib). 25754159
Zenke Y, Umemura S, Sugiyama E, Kirita K, Matsumoto S, Yoh K, Niho S, et al. Successful treatment with afatinib after grade 3 hepatotoxicity induced by both gefitinib and erlotinib in EGFR mutation-positive non-small cell lung cancer. Lung Cancer 2016; 99: 1-3. (57 year old man with NSCLC developed ALT elevations 7 weeks after starting gefinitib [bilirubin 2.0 mg/dL, ALT peak 594 U/L], which resolved upon stopping but he then developed worsening jaundice within a week of starting erlotinib [bilirubin 5.4 mg/dL, ALT normal], and later tolerated afatinib; genetic testing revealed Gilbert syndrome and "poor metabolizer" phenotype of CYP 3A5). 27565905
Ueda H, Hayashi H, Kudo K, Takeda M, Nakagawa K. Successful treatment with afatinib after gefitinib- and erlotinib-induced hepatotoxicity. Invest New Drugs 2016; 34: 797-9. (67 year old woman with metastatic NSCLC developed ALT elevations 16 weeks after starting gefitinib [ALT 223 U/L] which improved upon stopping, recurred with restarting gefitinib and later recurred 10 weeks after starting erlotinib [ALT 262 U/L), which improved on stopping but recurred even with lower doses, but subsequent ALT levels remained normal on switching to afatinib). 27550238
Toba H, Sakiyama S, Takizawa H, Tangoku A. Safe and successful treatment with afatinib in three postoperative non-small cell lung cancer patients with recurrences following gefitinib/erlotinib-induced hepatotoxicity. J Med Invest 2016; 63 (1-2): 149-51. (Two women and one man, ages 63 to 73 years with NSCLC developed ALT elevations 4-8 weeks after starting gefitinib [which recurred in one 6 weeks after switching to erlotinib], but all three tolerated long term afatinib [7 months] without recurrence of enzyme elevations). 27040072
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the tyrosine kinase inhibitors erlotinib and gefitinib which has been linked to serum enzyme elevations in 10-24% of patients and above 5 times ULN in 2-4% as well as individual cases of severe injuryy, some of which have been fatal). 27842767
Sugiyama E, Umemura S, Nomura S, Kirita K, Matsumoto S, Yoh K, Niho S, et al. Impact of single nucleotide polymorphisms on severe hepatotoxicity induced by EGFR tyrosine kinase inhibitors in patients with non-small cell lung cancer harboring EGFR mutations. Lung Cancer 2015; 90: 307-13. (Among 60 patients with NSCLC treated with gefinitib, 19 [32%] developed "severe" liver test abnormalities which was more frequent in those with poor metabolized phenotype [48% vs 14%]; 9 patients were switched to erlotinib and did not develop recurrence of severe injury). 26323212
Takeda M, Okamoto I, Nakagawa K. Pooled safety analysis of EGFR-TKI treatment for EGFR mutation-positive non-small cell lung cancer. Lung Cancer 2015; 88: 74-9. (A pooled analysis of 21 trials of tyrosine kinase inhibitors of EGFR found higher reported rates of "grade 3" hepatotoxicity with gefitinib [18%] than with erlotinib [5.4%] and afatinib [1.7%], and hepatotoxicity was listed as the cause of drug discontinuation in 25% of cases). 25704957
Park K, Tan EH, O'Byrne K, Zhang L, Boyer M, Mok T, Hirsh V, et al. Afatinib versus gefitinib as first-line treatment of patients with EGFR mutation-positive non-small-cell lung cancer (LUX-Lung 7): a phase 2B, open-label, randomised controlled trial. Lancet Oncol 2016; 17: 577-89. (Among 319 patients with EGFR mutant positive NSCLC treated with afatinib [40 mg] or gefitinib [250 mg] daily, progression- free survival was similar in both groups [11.0 vs 10.9 months] as were overall rates of adverse events, although ALT or AST elevations were less frequent with afatinib [all elevations 10% vs 24%, elevations above 5 times ULN 0% vs 1%] and one patient on gefitinib developed fatal acute liver failure). 27083334
Imai A, Hachiya T, Ikuyama Y, Sonehara K, Fujimori A, Shiba H, Atobe O. [Successful treatment of non-small cell lung cancer with afatinib after gefitinib-induced hepatotoxicity]. Gan To Kagaku Ryoho 2016; 43: 91-4. Japanese. (Have). 26809532
Wang J, Wu Y, Dong M, He X, Wang Z, Li J, Wang Y. Observation of hepatotoxicity during long-term gefitinib administration in patients with non-small-cell lung cancer. Anticancer Drugs 2016; 27: 245-50. (Among 101 patients with advanced NSCLC treated with genfitinib for 3-60 months, 40 [40%] developed abnormal liver tests which were above 5 times ULN in 4, but levels often resolved with continued therapy or remained in the mild range during long term use). 26633888
Liu Y, Zhang Y, Feng G, Niu Q, Xu S, Yan Y, Li S, Jing M. Comparison of effectiveness and adverse effects of gefitinib, erlotinib and icotinib among patients with non-small cell lung cancer: A network meta-analysis. Exp Ther Med 2017; 14: 4017-32. (In a network analysis of 7168 patients who received gefitinib, erlotinib or icotinib in 43 studies, clinical outcomes and rates of liver test abnormalities were similar among the three tyrosine kinase inhibitors). 29104622
Cho S, Yee J, Kim JY, Jeong Rhie S, Gwak HS. Effects of concomitant medication use on gefitinib-induced hepatotoxicity. J Clin Pharmacol 2018; 58: 263-8. (Among 497 Korean patients wiith lung cancer treated with gefitinib, 197 [40%] developed liver test abnormalities which occurred more frequently among those below the age of 65 [45%], and those receiving an H2 blocker or proton pump inihibitor [47%]). 28981161
Wu YL, Cheng Y, Zhou X, Lee KH, Nakagawa K, Niho S, Tsuji F, et al. Dacomitinib versus gefitinib as first-line treatment for patients with EGFR-mutation-positive non-small-cell lung cancer (ARCHER 1050): a randomised, open-label, phase 3 trial. Lancet Oncol 2017; 18: 1454-66. (Among 452 patients with advanced NSCLC treated with dacomitinib or gefitinib for a median duration of 22 months, progression free survival was slightly better with dacomitinib [14.7 vs 9.2 months] but severe adverse events were more frequent, although ALT elevations above 5 times ULN arose in less [1% vs 8%]). 28958502

## OTHER REFERENCE LINKS

1. Recent References on Gefitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Gefitinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gefitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gefitinib)